# Droxidopa

## OVERVIEW

### Introduction

Droxidopa is an orally available prodrug of norepinephrine that is used in the treatment of symptomatic orthostatic hypotension due to neurogenic causes of autonomic failure. Droxidopa has had limited clinical use, but has not been linked to serum enzyme elevations nor to instances of clinically apparent acute liver injury.

### Background

Droxidopa (drox" i doe' pa) is a prodrug of norepinephrine (noradrenaline) a major adrenergic neurotransmitter important in maintenance of sympathetic autonomic tone and normal blood pressure. Unlike norepinephrine, however, droxidopa does not cross the blood-brain barrier, so that its effects are restricted to the periphery where it acts on the smooth muscle of arteries and arterioles to maintain blood pressure, particularly in response to standing. In short term clinical trials, droxidopa showed modest effects in improving symptoms of postural hypotension in patients with neurogenic causes. The neurogenic causes of primary autonomic failure include Parkinson disease and multiple systemic atrophy (Shy Drager syndrome). Droxidopa was approved for use in the United States in 2014 and current recommendations are limited to treatment of orthostatic hypotension due to neurogenic causes. Droxidopa is available as capsules of 100, 200 and 300 mg. The typical initial dose is 100 mg three times daily, with subsequent titration based upon efficacy and tolerance to as much as 600 mg three times daily. Common side effects include headache, dizziness, nausea and hypertension. Rare instances of neuroleptic malignant syndrome have been reported with its use.

### Hepatotoxicity

Liver test abnormalities have not been reported in patients taking droxidopa, but the agent has had limited clinical use. There were no episodes of clinically apparent liver injury reported in the preregistration trials of droxidopa, and since its approval there have been no published reports of droxidopa hepatotoxicity. Thus, liver injury from droxidopa is likely to be rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Droxidopa is excreted largely unchanged in the urine and its hepatic metabolism is minimal, perhaps accounting for why hepatotoxicity is rare.

Drug Classes: Antiparkinson Agents, Other (Cardiovascular)

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Droxidopa – Northera®

DRUG CLASS

Antiparkinson Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Droxidopa)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Droxidopa | 23651-95-8 | C9-H11-N-O5 | Droxidopa Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 17 April 2017

Westfall TC, Westfall DP. Therapeutic uses of sympathomimetic drugs. Adrenergic agonists and antagonists. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 300-4. (Textbook of pharmacology and therapeutics).
Kaufmann H, Freeman R, Biaggioni I, Low P, Pedder S, Hewitt LA, Mauney J, et al.; NOH301 Investigators. Droxidopa for neurogenic orthostatic hypotension: a randomized, placebo-controlled, phase 3 trial. Neurology 2014; 83: 328-35. (Among 263 patients with neurogenic orthostatic hypotension treated with droxidopa in varying doses [100 to 600 mg], 162 responders then received droxidopa or placebo for 1 week, during which symptoms improved more in droxidopa treated subjects and side effects included headache, dizziness and syncope, while laboratory results showed no “clinically significant trends”). 24944260
Hauser RA, Isaacson S, Lisk JP, Hewitt LA, Rowse G. Droxidopa for the short-term treatment of symptomatic neurogenic orthostatic hypotension in Parkinson's disease (nOH306B). Mov Disord 2015; 30: 646-54. (Among 171 patients with orthostatic hypotension due to Parkinson disease who were treated with droxidopa or placebo for 10 weeks, symptoms of dizziness were improved with droxidopa therapy and side effects included headache, dizziness, nausea and hypertension; “Overall, …clinical laboratory values… showed no clinically significant trends or differences between treatment groups”). 25487613
Vannorsdall MD, Hariachar S, Hewitt LA. A randomized, placebo-controlled, phase 2 study of the efficacy and safety of droxidopa in patients with intradialytic hypotension. Postgrad Med. 2015; 127: 133-43. (Among 85 patients on hemodialysis for end stage renal disease who had symptomatic hypotension between dialysis events who were treated with droxidopa [400 or 600 mg three times daily] showed no differences in mean arterial pressure, while side effects were more frequent on droxidopa included nausea, headache, fatigue, sleep disturbance and pruritus). 25708022
Droxidopa (Northera) for neurogenic orthostatic hypotension. Med Lett Drugs Ther 2015; 57 (1471): 92-3. (Concise review of the mechanism of action, clinical efficacy, safety and costs of droxidopa shortly after its approval for use in the US; mentions side effects of hypertension, headache, dizziness and nausea, and possible severe side effects of neuroleptic malignant syndrome and exacerbation of ischemic heart disease and cardiac arrhythmias; no mention of ALT elevations or hepatotoxicity). 26079764
Isaacson S, Vernino S, Ziemann A, Rowse GJ, Kalu U, White WB. Long-term safety of droxidopa in patients with symptomatic neurogenic orthostatic hypotension. J Am Soc Hypertens 2016; 10: 755-62. (Among 350 patients with neurogenic orthostatic hypotension treated with droxidopa [100 to 600 mg three times daily] for an average of 1 year, there were no liver related serious adverse events or deaths and “laboratory values showed no trends or consistent changes from baseline that were considered clinically significant”; no mention of ALT elevations or hepatotoxicity). 27614923

## OTHER REFERENCE LINKS

1. Recent References on Droxidopa: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Droxidopa/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Droxidopa: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Droxidopa)